# Afamelanotide

## OVERVIEW

### Introduction

Afamelanotide is a melanocortin-1 receptor agonist that stimulates melanin production in the skin and is used to decrease pain and itching from light exposure in patients with erythropoietic protoporphyria and X-linked protoporphyria. Afamelanotide has not been linked to serum aminotransferase elevations during therapy nor to instances of idiosyncratic acute liver injury with symptoms and jaundice.

### Background

Afamelanotide (a fa mel” ano tide’) is a melanocortin-1 receptor (MC1-R) agonist that stimulates melanin production in the skin and is used to decrease pain and itching from light exposure in patients with erythropoietic protoporphyria (EPP) or X-linked protoporphyria (XLPP). EPP and XLPP are rare genetic diseases of heme synthesis that typically present in childhood with severe and painful photosensitivity. Although the clinical phenotypes of EPP and XLPP are closely similar, the underlying genetic and enzymatic defects are different. The cause of EPP, which accounts for 90% to 95% of clinical cases, is a deficiency in ferrochelatase, an enzyme that adds iron to protoporphyrin to create heme, which is the final step in heme synthesis. The cause of XLPP is a gain-of-function mutation in the erythroid form of 5-aminolevulinic acid synthase, which leads to overproduction of protoporphyrin (PP) beyond the capacity of developing red blood cells to convert the PP into heme and hemoglobin. As a result, protoporphyrin accumulates in red blood cells, plasma, and other tissues, including skin and liver. When exposed to light, protoporphyrin is activated and emits fluorescent light that, in turn, produces singlet oxygen, which initiates a cascade of free radical reactions that cause pain, edema, and inflammation, leading to phototoxic reactions. PP is hydrophobic and is not excreted into the urine, but rather must be taken up by hepatocytes and secreted into the bile. Excess PP can accumulate in hepatocytes and cholangiocytes and cause liver cell injury, sometimes with inflammation and fibrosis, a condition that has been called protoporphyric hepatopathy, which is severe in 2% to 3% of patients. Patients with EPP/XLPP also have an increased risk of pigmented gallstones, comprised chiefly of PP, and need for cholecystectomies. Persons with EPP/XLPP learn to avoid light exposure, which triggers not only pain, but also itching, redness and edema. They learn to avoid sunlight, remain indoors, and when outside to wear protective clothes, hats, gloves, and even masks. Afamelanotide is a modified amino acid analogue of alpha-melanocyte-stimulating hormone that binds to the MC1-R and increases the synthesis of melanin which darkens the skin and helps to absorb, scatter and quench the light that activates the excess protoporphyrin. Pilot studies followed by small randomized controlled trials demonstrated that afamelanotide treatment decreased the symptoms of photosensitivity, allowing patients to have more, but still limited, periods of light exposure. Prospective studies demonstrated an improvement in quality of life, employment, and activities of daily living in persons with EPP/XLPP treated with afamelanotide. Afamelanotide was approved in the United States in 2019 under the brand name Scenesse. Current indications are to increase pain-free light exposure in adults with a history of phototoxic reactions from EPP. The safety and efficacy of afamelanotide have not been proven in children, in whom it has been used off-label. Afamelanotide is available as injectable implants of 16 mg under the brand name Scenesse. The recommended regimen is a subcutaneous implant every 2 months. Afamelanotide is generally well tolerated but side effects can include injection site reactions, nausea, fatigue, dizziness, headache, and somnolence. Rare but potentially serious adverse events include melanocyte nevi and infections.

### Hepatotoxicity

Erythropoietic protoporphyria and X-linked protoporphyria are rare genetic diseases, and the pivotal trials of afamelanotide were conducted in a limited number of patients, so the full spectrum of hepatotoxicity may not be fully known. Furthermore, a proportion of untreated persons with EPP/XLPP have liver disease with mild, fluctuating elevations of serum aminotransferase levels; indeed, 2% to 5% develop significant liver disease with cholestatic features and cirrhosis, some of which may be due to gallstones which are common in patients with EPP/XLPP and others due to alcohol or other underlying liver diseases. Against this background, the clinical studies of afamelanotide were accompanied by minor serum enzyme elevations, but in rates that were similar to those receiving placebo and none reaching levels considered indicative of drug induced liver injury. In the three prospective placebo-controlled trials of afamelanotide in EPP/XLPP, there were no episodes of clinically apparent liver injury that arose during therapy, but a few patients developed evidence of chronic liver disease, cirrhosis, or complications of gallstones during follow up. These episodes arose long after afamelanotide was stopped and were considered due to the underlying liver disease or concurrent excessive alcohol use. Indeed, afamelanotide treatment is associated with slight decreases in protoporphyrin levels and may ameliorate the course of the EPP/XLPP-associated chronic liver injury. Since, its approval and more widescale use, there have been no reports of clinically apparent liver injury attributed to afamelanotide.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The reasons why afamelanotide might cause liver injury are not clear. It is a small, modified polypeptide that mimics melanocyte stimulating hormone. After uptake, it is metabolized intracellularly by proteases to its component amino acids by many cells. Allergic reactions and antibodies to afamelanotide are uncommon and it is not a substrate for hepatic cytochrome P450 enzymes.

### Outcome and Management

Afamelanotide has not been linked to liver injury, and monitoring of liver enzymes is not recommended during treatment. However, persons with EPP/XLPP are at an increased risk for developing liver disease and gallstones due to accumulation of toxic protoporphyrin for which reason screening for liver disease and ongoing monitoring is warranted.

Drug Class: Genetic Disorder Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Afamelanotide – Scenesse®

DRUG CLASS

Genetic Disorder Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Afamelanotide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Afamelanotide | 75921-69-6 | C78-H111-N21-O19

## ANNOTATED BIBLIOGRAPHY

References updated: 05 March 2024

Abbreviations: EPP, erythropoietic protoporphyria; MCR-1, melanocortin receptor, type 1; PP, protoporphyrin IX; XLPP, X-linked protoporphyria.

FDA multi-disciplinary review and evaluation. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2019/210797Orig1s000MultidisciplineR.pdf (The FDA clinical review of afamelanotide for efficacy and safety data in 125 subjects treated in 3 controlled trials submitted in support of approval, found adverse events were uncommon, generally transient, and mild-to-moderate in severity, and few were more frequent than in placebo recipients including implantation site reaction in 21% vs 10%, nausea in 19% vs 14%, throat pain 7% vs 4%, fatigue in 6% vs 3%, and dizziness in 4% vs 3%, with no hepatic severe adverse events during treatment and “no clinically meaningful changes in …liver enzymes...”).
Anstey AV, Hift RJ. Liver disease in erythropoietic protoporphyria: insights and implications for management. Gut. 2007;56:1009-18. (Review of liver disease of EPP which appears to be due to the excess protoporphyrin that is strongly hypophobic and insoluble in bile forming crystals with diffuse precipitation in hepatocytes and cholangiocytes that leads to inflammation and fibrosis; between 1% and 5% of patients with EPP are affected which can present as minor elevations in liver enzymes, or a cholestatic liver injury, or a progressive liver disease resulting in cirrhosis and end stage liver disease, unresponsive to ursodiol but reversible by liver transplantation but recurrence is common [~67%]). 17360790
Balwani M. Erythropoietic protoporphyria and X-linked protoporphyria: pathophysiology, genetics, clinical manifestations, and management. Mol Genet Metab. 2019;128:298-303. (Review of the genetics, pathophysiology, clinical features, associated liver injury, diagnosis, and management of EEP; no discussion of afamelanotide adverse events). 30704898
Harms J, Lautenschlager S, Minder CE, Minder EI. An alpha-melanocyte-stimulating hormone analogue in erythropoietic protoporphyria. N Engl J Med. 2009;360:306-7. (Among 5 patients with erythropoietic protoporphyria [EPP] treated with afamelanotide [20 mg twice daily for 60 days] tolerance to artificial light and melanin density increase with minimal adverse events and “no clinically important laboratory abnormalities”). 19144952
Grimes PE, Hamzavi I, Lebwohl M, Ortonne JP, Lim HW. The efficacy of afamelanotide and narrowband UV-B phototherapy for repigmentation of vitiligo. JAMA Dermatol. 2013;149:68-73. (Among 4 patients with generalized vitiligo treated with afamelanotide and narrowband ultra-violet [UV] B phototherapy, all developed a 50% or more repigmentation while adverse events included nausea, headache, dizziness, and one episode of heart palpitation; no mention of ALT elevations or hepatotoxicity). 23407924
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, no cases were attributed to therapies for porphyria). 25754159
Lim HW, Grimes PE, Agbai O, Hamzavi I, Henderson M, Haddican M, Linkner RV, et al. Afamelanotide and narrowband UV-B phototherapy for the treatment of vitiligo: a randomized multicenter trial. JAMA Dermatol. 2015;151:42-50. (Among 55 adults with generalized vitiligo treated with UV-B phototherapy for 4 months with or without afamelanotide for the first month, combination therapy led to a higher rate and speed of repigmentation and also adverse events of nausea [18%] and fatigue [11%], while skin related adverse events were similar in the two groups; no mention of ALT levels or hepatotoxicity). 25230094
Biolcati G, Marchesini E, Sorge F, Barbieri L, Schneider-Yin X, Minder EI. Long-term observational study of afamelanotide in 115 patients with erythropoietic protoporphyria. Br J Dermatol. 2015;172:1601-1612. (Among 115 adults with EEP treated with afamelanotide for up to 8 years at two porphyria centers in Europe, 3 had no improvement in symptoms and 23% discontinued treatment, while quality of life measures improved in those on treatment and only minor adverse events occurred which were largely nausea and gastrointestinal complaints; no mention of ALT levels or hepatic adverse events). 25494545
Langendonk JG, Balwani M, Anderson KE, Bonkovsky HL, Anstey AV, Bissell DM, Bloomer J, et al. Afamelanotide for erythropoietic protoporphyria. N Engl J Med. 2015;373:48-59. (Among 168 patients enrolled in two controlled trials of afamelanotide vs placebo implants, pain free time of light exposure increased as did quality of life, while adverse event rates were similar except for implant-site discoloration, and no liver related severe adverse events; no mention of ALT elevations). 26132941
Balwani M, Bloomer J, Desnick R; Porphyrias Consortium of the NIH-Sponsored Rare Diseases Clinical Research Network. Erythropoietic Protoporphyria, Autosomal Recessive. 2012 Sep 27 [updated 2017 Sep 7]. In: Adam MP, Feldman J, Mirzaa GM, Pagon RA, Wallace SE, Bean LJH, Gripp KW, Amemiya A, editors. GeneReviews® [Internet]. Seattle (WA): University of Washington, Seattle; 1993–2024. (Review of the clinical features, diagnosis and management of EPP, mentions afamelanotide but does not describe its side effects or tolerance).
Lane AM, McKay JT, Bonkovsky HL. Advances in the management of erythropoietic protoporphyria—role of afamelanotide. Appl Clin Genet 2016;9:179-189. (Review of the chemistry and pharmacology of afamelanotide and results of the preclinical and clinical trials up to 2016). 28003770
Wensink D, Wagenmakers MAEM, Barman-Aksözen J, Friesema ECH, Wilson JHP, van Rosmalen J, Langendonk JG. Association of afamelanotide with improved outcomes in patients with erythropoietic protoporphyria in clinical practice. JAMA Dermatol. 2020;156:570-575. (Among 121 adults with EPP followed at a single referral center in the Netherlands who underwent serial assessments, employment status and quality of life improved after starting afamelanotide therapy with many elements approaching the average of the Dutch population). 32186677
Wensink D, Coenen S, Wilson JHP, Wagenmakers MAEM, Langendonk JG. Liver involvement in patients with erythropoietic protoporphyria. Dig Liver Dis. 2022;54:515-520. (Among 114 patients with EEP without a known history of liver disease seen at a single referral center in the Netherlands undergoing evaluation including elastography, 7 [6%] had elevated liver enzymes, 28 [26%] had gallstones or history of cholecystectomy, 18 of 60 [29%] had elevated an CAP score suggestive of hepatic steatosis, 10 of 104 [10%] had an increased hepatic stiffness [7 as F2-portal fibrosis, 3 as F3-bridging fibrosis, none as F4-cirrhosis], and while some cases could be explained by nonalcoholic steatohepatitis, none could be explained by alcohol related liver disease). 34475006
Wensink D, Wagenmakers MAEM, Wilson JHP, Langendonk JG. Erythropoietic protoporphyria in the Netherlands: Clinical features, psychosocial impact and the effect of afamelanotide. J Dermatol. 2023;50:445-452. (Among 121 adults with EPP followed at a single referral center in the Netherlands who underwent serial assessments, employment status and quality of life improved after starting afamelanotide therapy with many elements approaching the average of the Dutch population). 36579412
Minder AE, Schneider-Yin X, Zulewski H, Minder CE, Minder EI. Afamelanotide Is associated with dose-dependent protective effect from liver damage related to erythropoietic protoporphyria. Life (Basel). 2023;13:1066. (Among 70 adults with EPP followed at a single Swiss referral center from 1993 to 2022, serum levels of protoporphyrin correlated with serum ALT and bilirubin elevations and appeared to be decreased with afamelanotide therapy, suggesting that it may slow the progress of liver disease in patients with EPP). 37109595
Levy C, Dickey AK, Wang B, Thapar M, Naik H, Keel SB, Saberi B, et al: on behalf of the Porphyrias Consortium of the Rare Diseases Clinical Network. Evidence-based consensus guidelines for the diagnosis and management of protoporphyria-related liver dysfunction in erythropoietic protoporphyria and X-linked protoporphyria. Hepatology 79: 731-743, 2024. (Recent consensus guidelines regarding the evaluation and long-term assessment and management of the liver in patients with EPP and XLPP). 37505211

## OTHER REFERENCE LINKS

Recent References on Afamelanotide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Afamelanotide/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))

Trials on Afamelanotide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Afamelanotide)